# Piperacillin

## OVERVIEW

### Introduction

Piperacillin is an extended spectrum ureidopenicillin and is used to treat moderate-to-severe infections due to susceptible organisms. Piperacillin has been linked with idiosyncratic liver injury, but only rarely and in isolated case reports.

### Background

Piperacillin (pi" per a sil' in) is a fourth generation, extended spectrum penicillin which is used for moderate-to-severe infections caused by susceptible agents, such as (but not limited to) Escherichia coli, Hemophilus influenzae, Listeria monocytogenesis, Neisseria gonorrhoeae, Proteus mirabilis, Salmonella, Shigella, Staphylococcus aureus (non-penicillinase producing), Staphylococcus epidermidis, and Streptococcus pneumoniae. Piperacillin was approved for use in the United States in 1981 and is generally reserved for severe infections requiring parenteral therapy. Piperacillin is available in parenteral form (intramuscular and intravenous) generically and under the trade name Pipracil. Piperacillin is often combined with a beta lactamase inhibitor (tazobactam) to prevent bacterial resistance. The recommended regimen is 2 to 4 grams daily in divided doses given every 4 to 6 hours usually for 5 to 7 days. Common side effects include headache, dizziness, nausea, diarrhea, constipation, skin rash and hypersensitivity reactions. Rare but potentially severe adverse events include anaphylactic and hypersensitivity reactions, Stevens Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

Patients on intravenous piperacillin may have transient and mild-to-moderate serum aminotransferase elevations in up to 12% of patients, but these are of little clinical significance and not more common than with comparative parenteral antibiotics. Hepatic injury was more commonly reported with mezlocillin, a related extended spectrum ureidopenicillin which has been withdrawn from use. Rare instances of idiosyncratic liver injury have been reported in persons receiving piperacillin. The liver injury is typically cholestatic arising within 1 to 6 weeks of starting therapy. The injury can be severe, but is generally self-limited once piperacillin is stopped. The features of the hepatotoxicity resemble those of other penicillins. The cholestatic hepatitis caused by piperacillin and other penicillins can be prolonged and lead to persistent cholestasis (vanishing bile duct syndrome) or persistent elevations in serum alkaline phosphatase suggestive of partial bile duct loss. Most cases of liver injury related to piperacillin are linked to the combination of piperacillin with the beta-lactamase inhibitor tazobactam (Zosyn and generics), which is more commonly used than piperacillin alone.

Likelihood score: B (known rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with piperacillin use is probably hypersensitivity or allergy. Instances of cross reactivity with other penicillins and worsening of cholestasis with reintroduction of the agent have been reported.

### Outcome and Management

In the few cases that have been described, patients have recovered within 1 to 3 months once the drug is stopped. Patients with piperacillin induced hepatitis should avoid reexposure to other penicillins and should take cephalosporins with caution.

References to the safety and potential hepatotoxicity of piperacillin are provided in the drug record on Piperacillin-Tazobactam.

Drug Class: Antiinfective Agents, Penicillins (Fourth Generation)

Other Drugs in the Class: Piperacillin-Tazobactam, Ticarcillin, Ticarcillin-Clavulanate

## CASE REPORT

### Case 1. Cholangiopathy with possible causation by piperacillin.(1)

A 20 year old man underwent surgery for abdominal trauma, receiving a single dose of piperacillin and 3 days of imipenem-cilastatin postoperatively and subsequently developed fever, fatigue, and pruritus starting 15 days after surgery. He had moderate elevations in serum aminotransferase and alkaline phosphatase levels and serum bilirubin subsequently rose and peaked at 4.8 mg/dL (Table). He had no history of liver disease or risk factors for viral hepatitis. He had not used alcohol and took no other medications after surgery. He was admitted for evaluation. Ultrasound and CT scan of the abdomen were negative. Tests for viral hepatitis and autoimmune liver disease were negative. A liver biopsy showed intrahepatic cholestasis with portal inflammation. Lymphocyte transformation tests were reported to be positive with both piperacillin and imipenem-cilastatin. He recovered rapidly and all tests had returned to normal when seen two months later.

#### Key Points

Medication: | Piperacillin, 1 gram IV bolus
Pattern: | Mixed (R=4.9)
Severity: | 3+ (jaundiced and hospitalization)
Latency: | 15 days to symptoms, 22 days to jaundice
Recovery: | ~2 months
Other medications: | Imipenem-cilastatin (4 g daily IV for 3 days) and acetaminophen (4 g daily orally for 3 days) in the postoperative period.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 210 | 90 | | Surgery
Emergency surgery small bowel perforation: one dose of piperacillin given IV
4 days | 3 days | 83 | 39 | | Discharged
Developed fatigue followed by pruritus ~day 15 after surgery
21 days | 20 days | 345 | 201 | 0.9
22 days | 21 days | 654 | 416 | 2.9
25 days | 24 days | 669 | 559 | 4.7 | Liver biopsy
35 days | 34 days | 210 | 531 | 1.2
3months | 3 months | 13 | 79 | 0.8
Normal Values | | <37 | <108 | <1.2

#### Comment

The young man clearly had drug induced liver disease with a mixed pattern of serum enzyme elevations and mild cholestasis that resolved completely in follow up. The difficulty is knowing which agent or agents was responsible. He received only one dose of piperacillin and less than 3 days of imipenem/cilastatin. Neither of these agents are common causes of drug induced liver disease. One might also question whether a halogenated anesthetic was used that might have caused liver injury and whether acetaminophen may have contributed. Hepatotoxicity from these agents, however, is usually more rapid in onset and hepatocellular in character. The pattern of injury was most compatible with a penicillin induced hepatic reaction. Lymphocyte transformation tests may be helpful, but their reliability in discriminating the cause of hepatic injury remains unproven; in this instance reactivity was found with both agents. This patient should probably be advised not to receive penicillin in the future.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Piperacillin – Generic, Pipracil®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=piperacillin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Piperacillin | 59703-84-3 | H26-N5-Na-O7-S

## CITED REFERENCE

1 Quattropani C, Schneider M, Helbling A, Zimmermann A, Krähenbühl S. (2001). Cholangiopathy after short-term administration of piperacillin and imipenem/cilastatin. Liver.

## OTHER REFERENCE LINKS

1 Recent References on Piperacillin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Piperacillin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Piperacillin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Piperacillin)